# Stinging Nettle

## OVERVIEW

### Introduction

Stinging Nettle is an extract of either the leaves and flowering parts or the roots of Urtica dioica, a tall herbaceous plant found throughout the world in temperate and humid areas. Extracts of the leaves of stinging nettle are use in foods and animal feed and are purported to be beneficial for many conditions. Extracts of the roots are purported to relieve urinary symptoms in patients with benign prostatic hypertrophy. Stinging nettle extracts are generally well tolerated and have not been implicated in instances of serum aminotransferase elevations or cases of clinically apparent liver injury.

### Background

Stinging nettle (also simply called nettle or stinger) is derived from the plant Urtica dioica, a tall herbaceous weed found in temperate and humid areas throughout the world. Stinging nettle is so named because contact with fresh leaves can cause a transient stinging skin rash, the result of histamine, acetyl choline and other irritants that are injected into the skin by minute sharp pointed hairs (spicules or trichomes) on the surface of the leaves. Processing of the leaves and flowering parts of the plant destroy the stinging spicules and can be taken orally or consumed in food without stinging or irritation. Nettle is widely used as a food, flavoring additive, animal feed, fiber, and coloring agent. The botanical extracts have been purported to have beneficial effects for infections, inflammation, hay fever, asthma, arthritis, high blood pressure, diabetes, and even Gulf War syndrome. The bases of these claims have not been substantiated in controlled trials in human, but laboratory studies suggest that components of stinging nettle leaves have antioxidant and antiinflammatory properties. More frequently used are extracts of the roots of Urtica dioica, which have been reported to increase urinary flow and decrease symptoms of benign prostatic hypertrophy. Stinging nettle roots contain multiple sterols, lectins, polysaccharides, hydroxycoumarins, and lignans, but the active ingredient with effects on lower urinary tract symptoms is not known. Laboratory studies suggest that the nettle root lectin agglutin may bind to or block sex hormone synthesis or pathways of activity and thus act on prostatic hypertrophy. The rigor and reproducibility of trials of stinging nettle extracts have been questioned, and they are not approved for any medical condition in the United States. Stinging nettle is found in multiple over-the-counter, commercial forms as capsules, tablets or solutions, typically recommended in doses of 300 to 600 mg daily. The commercially available products include either leaf or root extracts and sometimes both. Stinging nettle extracts are well tolerated with minimal or no adverse events, which may include headache, nausea, diarrhea, constipation or abdominal discomfort. Raw fresh stinging nettle leaves cause skin rash and urticaria and are sometimes used as a counterirritant or even as a publishment; they should not be taken by mouth.

### Hepatotoxicity

In multiple short- and long-term clinical trials of different preparations of stinging nettle extracts, adverse side effects were described as uncommon and minimal with no mention of either hepatotoxicity or ALT elevations. Few prospective studies included monitoring of liver tests, but those that did reported no change in serum aminotransferase levels. Despite widespread use, there have been no published reports of serum enzyme elevations or clinically apparent liver injury attributable to stinging nettle root or leaf extracts.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which stinging nettle might cause liver injury is unknown.

### Outcome and Management

Hepatotoxicity from extracts of stinging nettle roots, leaves and flowering parts has not been reported.

Drug Class: Herbal and Dietary Supplements

Other names: Nettle, Common Nettle, Stinger, Bichu, Ortie, Urtica.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Stinging Nettle – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Stinging Nettle | 84012-40-8 (https://pubchem.ncbi.nlm.nih.gov/substance/135342067) | Herbal | Not Applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 03 March 2023

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not nettle).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of stinging nettle).
Stinging Nettle. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 792-797. (Compilation of short monographs on herbal medications and dietary supplements).
Wikipedia. https://en.wikipedia.org/wiki/Urtica_dioica (Wikipedia chapter on Urtica dioica with an excellent description of the plant, its etymology, distribution, ecology, uses and cultural history including Shakespeare’s adoption of the English meaning of nettle: “out of this nettle, danger, we pluck this flower, safety” from Henry IV, part 1).
Kulze A, Greaves M. (1988). Contact urticaria caused by stinging nettles. Br J Dermatol. (Commentary on the contact urticaria caused by skin exposure to stinging nettle leaves that is transient but can last for up to 24 hours, produced by minute hair-like spicules with sharp ends on the leaf surface that penetrate the skin, injecting a solution of histamine, acetylcholine, serotonin and other irritants).
Wilt TJ, Ishani A, Rutks I, MacDonald R. (2000). Phytotherapy for benign prostatic hyperplasia. Public Health Nutr. (Systematic review of the literature on the efficacy of herbal products used for benign prostatic hyperplasia concludes that there is no convincing evidence supporting the use of Urtica dioica).
Melo EA, Bertero EB, Rios LA, Mattos D. (2002). Evaluating the efficiency of a combination of Pygeum africanum and stinging nettle (Urtica dioica) extracts in treating benign prostatic hyperplasia (BPH): double-blind, randomized, placebo controlled trial. Int Braz J Urol. (Among 49 men with symptomatic benign prostatic hypertrophy treated with a fixed combination of Pygeum africanum and Urtica dioica extracts vs placebo for six months, rates of symptomatic improvement and adverse events were similar in both groups and there were no serious adverse events; no mention of ALT elevations or hepatotoxicity).
Schneider T, Rübben H. B. (2004). Urologe A. (Among 226 men with symptomatic benign prostatic hypertrophy treated with stinging nettle root extract [Bazoton: 429 mg] or placebo daily for 52 weeks, symptom scores improved slightly more with the extract [-5.7 vs -4.8 points], while urinary flow and residual volume measurements were similar and adverse event rates were less; no mention of ALT levels or hepatotoxicity).
Lopatkin N, Sivkov A, Walther C, Schläfke S, Medvedev A, Avdeichuk J, Golubev G, et al. (2005). Long-term efficacy and safety of a combination of sabal and urtica extract for lower urinary tract symptoms—a placebo-controlled, double-blind, multicenter trial. World J Urol. (Among 219 men with benign prostatic hypertrophy who participated in a randomized controlled trial of a commercial herbal fixed-dose combination of sabal and stinging nettle vs placebo and were then treated with the product for another 96 weeks, improvement in symptoms was maintained, adverse event rates were similar to that in the placebo phase, and there were no treatment related serious adverse events; no mention of ALT elevations or hepatotoxicity).
Safarinejad MR. (2005). Urtica dioica for treatment of benign prostatic hyperplasia: a prospective, randomized, double-blind, placebo-controlled, crossover study. J Herb Pharmacother. (Among 558 men with symptomatic benign prostatic hypertrophy in a placebo controlled trial, Urtica dioica therapy was associated with a higher rate of symptom improvement [81% vs 16%], increase in urinary peak flow, decrease in post-void residual volume, and decrease in prostate size, but no change in PSA or testosterone levels and “no side effects were identified in either group).
Popa G, Hägele-Kaddour H, Walther C. (2005). MMW Fortschr Med. (Among 40 adult men with benign prostatic hypertrophy treated with an herbal combination product of stinging nettle and sabal palmetto extracts vs placebo for 24 weeks, urinary symptoms of frequency and urgency as well as quality of life measures improved more in the herbal product treated subjects; no mention of adverse events, ALT elevations or hepatotoxicity).
Chrubasik JE, Roufogalis BD, Wagner H, Chrubasik S. (2007). A comprehensive review on the stinging nettle effect and efficacy profiles. Part II: urticae radix. Phytomedicine. (Review of the efficacy and possible mechanism of action of stinging nettle root extract in benign prostatic hypertrophy concludes that the clinical evidence of efficacy is promising yet unproven, but that it is well tolerated with minimal adverse effects).
Randall C, Dickens A, White A, Sanders H, Fox M, Campbell J. (2008). Nettle sting for chronic knee pain: a randomised controlled pilot study. Complement Ther Med. (Among 42 patients with chronic knee pain treated with topical application of stinging nettle leaves [Urtica dioica] or a non-stinging nettle leaves [Urtica galeopsifolia] to both knees 3 times for 10 minutes once daily for 7 days, there was no differences in changes in pain or stiffness scores and the side effect of stinging was usually but not always short lived and tolerated).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found none attributed to stinging nettle).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not stinging nettle).
Pavone C, Abbadessa D, Tarantino ML, Oxenius I, Laganà A, Lupo A, Rinella M. (2010). Urologia. (Among 320 men with lower urinary tract symptoms due to benign prostatic hypertrophy or chronic prostatitis treated with a fixed combination of Serenoa repens [320 mg], Urtica dioica [120 mg] and Pinus pinaster [5 mg] once daily for 1 to 12 months, urinary symptoms improved in 85% of patients but prostate volume and urinary flow rates did not change; no discussion of adverse events or mention of ALT elevations or hepatotoxicity).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements but does not list or mention stinging nettle).
Kianbakht S, Khalighi-Sigaroodi F, Dabaghian FH. (2013). Improved glycemic control in patients with advanced type 2 diabetes mellitus taking Urtica dioica leaf extract: a randomized double-blind placebo-controlled clinical trial. Clin Lab. (Among 92 patients with type 2 diabetes and poor control on standard antidiabetic medications treated with stinging nettle [500 mg] or placebo 3 times daily for 3 months, fasting blood glucose, 2 hour postprandial glucose and HbA1c levels decreased with the herbal product but not with placebo, and there were no adverse effects, and no effect of treatment on serum creatinine, ALT and AST levels).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the General population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 15 of which [16%] were attributed to HDS products, but none were listed as containing stinging nettle).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention stinging nettle).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to stinging nettle).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss stinging nettle).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of stinging nettle).
Younger J, Donovan EK, Hodgin KS, Ness TJ. (2021). A placebo-controlled, pseudo-randomized, crossover trial of botanical agents for Gulf War illness: Reishi mushroom (Ganoderma lucidum), Stinging Nettle (Urtica dioica), and Epimedium (Epimedium sagittatum). Int J Environ Res Public Health. (In a crossover study of 30-day courses of high and low doses of three herbal preparations [10 patients each] or placebo, Gulf War illness symptom scales improved with high doses of stinging nettle leaf extract daily [1305 mg] compared to placebo [p=0.048], but not with low doses [435 mg] or with Reishi mushrooms or Epimedium).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while stinging nettle is not mentioned).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; stinging nettle is not discussed).

## OTHER REFERENCE LINKS

1 Recent References on Stinging Nettle: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Stinging+Nettle+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Stinging Nettle: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Stinging%20Nettle)